# Quercetin

## OVERVIEW

### Introduction

Quercetin is a flavonoid found in many foods and herbs and is a regular component of a normal diet. Extracts of quercetin have been used to treat or prevent diverse conditions including cardiovascular disease, hypercholesterolemia, rheumatic diseases, infections and cancer but have not been shown to be effective in clinical trials for any medical condition. Quercetin as a nutritional supplement is well tolerated and has not been linked to serum enzyme elevations or to episodes of clinically apparent liver injury.

### Background

Quercetin is a flavonoid found in many foods and herbs that has been purported to be beneficial to health, improving metabolic function, modulating inflammation and decreasing serum cholesterol. Quercetin is found in high concentrations in apples, berries, green beans, asparagus, broccoli, tomatoes, onions, beer and red wine as well as in several herbs include Ginkgo biloba, St. John’s wort, milk thistle and American elder, the typical Western diet having an estimated intake of 4 to 40 mg daily. The beneficial effects of quercetin have been suggested by several studies of human nutrition which have shown decreases in morbidity and mortality associated with higher intake of quercetin-rich foods such as fruits and green vegetables. Flavonoids have antioxidant effects that may protect against cell injury. In vitro, antioxidants such as quercetin have been shown to decrease oxidation of cholesterol esters which appears to play a role in the pathogenesis of atherosclerosis. Quercetin also has antiinflammatory activity inhibiting cyclooxygenase enzymes, synthesis of leukotrienes and prostaglandins and inhibiting histamine release. In cell culture and animal models, quercetin appears to have anticarcinogenic effects which have led to its evaluation in several forms of cancer. Finally, quercetin has been purported to improve athletic performance and reduce postexercise inflammation and oxidative stress. The diverse potential beneficial effects of quercetin have led it to be marketed in multiple dietary supplements with many health claims. Quercetin is available as an over-the-counter nutritional supplement typically in doses of 500 to 1000 mg daily. Quercetin is also frequently a component of multiingredient dietary supplements advertised as beneficial for general health, weight loss, body building and boosting energy. Quercetin is well tolerated and generally reported as having no discernable adverse effects. Abdominal discomfort, nausea and headache have been reported in some studies, but generally at low rates that are similar to those with placebo therapy.

### Hepatotoxicity

Quercetin supplements have not been linked serum aminotransferase elevations during therapy, although there have been few focused studies of its hepatic safety. Furthermore, there have been no published reports of clinically apparent liver injury attributable to quercetin. Indeed, many in vitro and in vivo studies have shown that quercetin protects against hepatic injury caused by drugs and toxins including acetaminophen and cancer chemotherapeutic agents. These hepatoprotective effects have not been demonstrated in prospective clinical trials in humans.

Likelihood score: E (unlikely cause of clinically apparent liver injury).

Other Names: Often a component in Bioflavonoid Extracts

Drug Class: Herbal and Dietary Supplements

## PRODUCT INFORMATION

REPRESENTATIVE TRADE NAMES

Quercetin – Generic

DRUG CLASS

Herbal and Dietary Supplements

SUMMARY INFORMATION

Fact Sheet on Dietary Supplements for Exercise and Athletic Performance, NIH (https://ods.od.nih.gov/factsheets/ExerciseAndAthleticPerformance-HealthProfessional/)

## CHEMICAL FORMULA AND STRUCTURE

DRUG | CAS REGISTRY NUMBER | MOLECULAR FORMULA | STRUCTURE
Quercetin | 117-39-5 | C15-H10-O7

## ANNOTATED BIBLIOGRAPHY

References updated: 28 March 2020

Zimmerman HJ. Unconventional drugs. Miscellaneous drugs and diagnostic chemicals. In, Zimmerman, HJ. Hepatotoxicity: the adverse effects of drugs and other chemicals on the liver. 2nd ed. Philadelphia: Lippincott,1999: pp. 731-4. (Expert review of hepatotoxicity published in 1999; several herbal medications linked to liver injury are discussed, but quercetin is not mentioned).
Seeff L, Stickel F, Navarro VJ. Hepatotoxicity of herbals and dietary supplements. In, Kaplowitz N, DeLeve LD, eds. Drug-induced liver disease. 3rd ed. Amsterdam: Elsevier, 2013, pp. 631-58. (Review of hepatotoxicity of herbal supplements, does not mention quercetin).
Quercetin. In, PDR for Herbal Medicines. 4th ed. Montvale, New Jersey: Thomson Healthcare Inc. 2007: pp. 1001-3. (Compilation of short monographs on herbal medications and nutritional supplements).
Shoskes DA, Zeitlin SI, Shahed A, Rajfer J. (1999). Quercetin in men with category III chronic prostatitis: a preliminary prospective, double-blind, placebo-controlled trial. Urology. (Among 30 men with symptoms of prostatitis treated with quercetin [500 mg twice daily] or placebo for 1 month, improvement in symptom scores was greater with quercetin than placebo and side effects were minimal; no mention of ALT elevations or hepatotoxicity).
Russo MW, Galanko JA, Shrestha R, Fried MW, Watkins P. (2004). Liver transplantation for acute liver failure from drug-induced liver injury in the United States. Liver Transpl. (Among ~50,000 liver transplants reported to UNOS between 1990 and 2002, 270 [0.5%] were done for drug induced acute liver failure, including 7 [5%] for herbal medications, but none were attributed to quercetin).
Shoskes D, Lapierre C, Cruz-Correa M, Muruve N, Rosario R, Fromkin B, Braun M, et al. (2005). Beneficial effects of the bioflavonoids curcumin and quercetin on early function in cadaveric renal transplantation: a randomized placebo controlled trial. Transplantation. (Among 43 patients undergoing renal transplantation treated with a combination of curcumin [480 mg] and quercetin [20 mg] or placebo, serum creatinine improved more rapidly with the herbal supplement and side effects were minimal, although one subject developed transient “unexplained” elevations in “liver function tests”).
Andrade RJ, Lucena MI, Fernández MC, Pelaez G, Pachkoria K, García-Ruiz E, García-Muñoz B, et al. (2005). Drug-induced liver injury: an analysis of 461 incidences submitted to the Spanish Registry over a 10-year period. Gastroenterology. (Reports of drug induced liver injury to a Spanish network found 570 cases, herbal medications accounted for 9 cases but none were attributed to quercetin).
Chalasani N, Fontana RJ, Bonkovsky HL, Watkins PB, Davern T, Serrano J, Yang H, Rochon J, Drug Induced Liver Injury Network (DILIN). (2008). Causes, clinical features, and outcomes from a prospective study of drug-induced liver injury in the United States. Gastroenterology. (Among 300 cases of drug induced liver disease in the US collected between 2004 and 2008, 9% of cases were attributed to herbal medications, but quercetin was not specifically implicated in any of the cases).
García-Cortés M, Borraz Y, Lucena MI, Peláez G, Salmerón J, Diago M, Martínez-Sierra MC, et al. (2008). Rev Esp Enferm Dig. (Among 521 cases of drug induced liver injury submitted to Spanish registry, 13 [2%] were due to herbals, but none specifically to quercetin).
Jacobsson I, Jönsson AK, Gerdén B, Hägg S. (2009). Spontaneously reported adverse reactions in association with complementary and alternative medicine substances in Sweden. Pharmacoepidemiol Drug Saf. (Review of 778 spontaneous reports of adverse reactions to herbals to Swedish Registry; no specific mention of quercetin).
Reuben A, Koch DG, Lee WM, Acute Liver Failure Study Group. (2010). Drug-induced acute liver failure: results of a U.S. multicenter, prospective study. Hepatology. (Among 1198 patients with acute liver failure enrolled in a US prospective study between 1998 and 2007, 133 [11%] were attributed to drug induced liver injury of which 12 [9%] were due to herbals, but none were attributed to quercetin).
Bigelman KA, Fan EH, Chapman DP, Freese EC, Trilk JL, Cureton KJ. (2010). Effects of six weeks of quercetin supplementation on physical performance in ROTC cadets. Mil Med. (Among 57 ROTC college students treated with a 6 week course of quercetin vs placebo, measures of physical fitness were similar in quercetin- and placebo-treated subjects; no mention of adverse events).
Stickel F, Kessebohm K, Weimann R, Seitz HK. (2011). Review of liver injury associated with dietary supplements. Liver Int. (Review of current understanding of liver injury from herbals and dietary supplements focusing upon Herbalife and Hydroxycut products, green tea, usnic acid, Noni juice, Chinese herbs, vitamin A and anabolic steroids; quercetin not discussed).
Teschke R, Wolff A, Frenzel C, Schulze J, Eickhoff A. (2012). Herbal hepatotoxicity: a tabular compilation of reported cases. Liver Int. (A systematic compilation of all publications on the hepatotoxicity of specific herbals identified 185 publications on 60 different herbs, herbal drugs and supplements, but quercetin is not listed).
Björnsson ES, Bergmann OM, Björnsson HK, Kvaran RB, Olafsson S. (2013). Incidence, presentation and outcomes in patients with drug-induced liver injury in the general population of Iceland. Gastroenterology. (In a population based study of drug induced liver injury from Iceland, 96 cases were identified over a 2 year period, including 15 [16%] due to herbal and dietary supplements, none of which listed quercetin as a component).
Navarro VJ, Barnhart H, Bonkovsky HL, Davern T, Fontana RJ, Grant L, Reddy KR, et al. (2014). Liver injury from herbals and dietary supplements in the U.S. Drug-Induced Liver Injury Network. Hepatology. (Among 85 cases of HDS associated liver injury [not due to anabolic steroids] enrolled in a US prospective study between 2004 and 2013, quercetin was not listed among the components of products taken by patients).
Seeff LB, Bonkovsky HL, Navarro VJ, Wang G. (2015). Herbal products and the liver: a review of adverse effects and mechanisms. Gastroenterology. (Extensive review of possible beneficial as well as harmful effects of herbal products on the liver does not mention or discuss quercetin).
Chalasani N, Bonkovsky HL, Fontana R, Lee W, Stolz A, Talwalkar J, Reddy KR, et al., United States Drug Induced Liver Injury Network. (2015). Features and outcomes of 899 patients with drug-induced liver injury: The DILIN Prospective Study. Gastroenterology. (Among 899 cases of drug induced liver injury enrolled in a prospective database between 2004 and 2012, HDS were implicated in 145 [16%], the single major herbal cause being green tea and no case implicating quercetin [Navarro et al Hepatology 2014]).
García-Cortés M, Robles-Díaz M, Ortega-Alonso A, Medina-Caliz I, Andrade RJ. (2016). Hepatotoxicity by dietary supplements: A tabular listing and clinical characteristics. Int J Mol Sci. (Listing of published cases of liver injury from HDS products, does not include specific mention of quercetin).
Serban MC, Sahebkar A, Zanchetti A, Mikhailidis DP, Howard G, Antal D, Andrica F, et al., Lipid and Blood Pressure Meta‐analysis Collaboration (LBPMC) Group. (2016). Effects of quercetin on blood pressure: a systematic review and meta-analysis of randomized controlled trials. J Am Heart Assoc. (Systematic review of 7 controlled trials in 587 patients comparing quercetin [100 to 1000 mg daily] to placebo given for 4-10 weeks for its effect on blood pressure found a mild effect particularly with doses of 500 mg or above and that it was “safe and well tolerated…with no report of serious adverse events”).
Panche AN, Diwan AD, Chandra SR. (2016). Flavonoids: an overview. J Nutr Sci. (Review of structure, distribution and function of the flavonoids, natural plant polyphenols found largely in fruits and vegetables that have a multitude of functions and may have health benefits in humans).
Brown AC. Liver toxicity related to herbs and dietary supplements: Online table of case reports. Part 2 of 5 series. Food Chem Toxicol 2017; 107 (Pt A): 472-501. (Description of an online compendium of cases of liver toxicity attributed to HDS products; quercetin is not mentioned or discussed).
de Boer YS, Sherker AH. (2017). Herbal and dietary supplement-induced liver injury. Clin Liver Dis. (Review of the frequency, clinical features, patterns of injury and outcomes of HDS hepatotoxicity with specific mention of anabolic steroids, black cohosh, germander, green tea, kava, pyrrolizidine alkaloids and proprietary multiingredient dietary supplements [MIDS]; does not mention quercetin).
Vega M, Verma M, Beswick D, Bey S, Hossack J, Merriman N, Shah A, et al., Drug Induced Liver Injury Network (DILIN). (2017). The incidence of drug- and herbal and dietary supplement-induced liver injury: preliminary findings from gastroenterologist-based surveillance in the population of the State of Delaware. Drug Saf. (A prospective, population based registry of cases of drug induced liver injury occurring in Delaware during 2014, identified 20 cases [2.7 per 100,000] overall, including 6 due to HDS products, all of which were proprietary multiingredient products, none specifically listing quercetin as a component).
Andres S, Pevny S, Ziegenhagen R, Bakhiya N, Schäfer B, Hirsch-Ernst KI, Lampen A. (2018). Safety aspects of the use of quercetin as a dietary supplement. Mol Nutr Food Res. (Extensive review of the safety of quercetin supplements from the German Federal Institute for Risk Assessment focusing upon possible carcinogenicity, reproductive, androgenic and estrogenic effects and drug interactions, concludes that there is inadequate information on the safety of quercetin supplements in humans and that patients “consult a physician prior to the use”; no mention of hepatotoxicity).
Huang H, Liao D, Dong Y, Pu R. (2019). Clinical effectiveness of quercetin supplementation in the management of weight loss: a pooled analysis of randomized controlled trials. Diabetes Metab Syndr Obes. (Systematic review of 9 controlled trials in 525 patients comparing quercetin [100 to 1000 mg daily] to placebo given for 2-12 weeks found no evidence for an effect on body weight or waist circumference and “treatment was well tolerated, and no drug-related adverse reactions were reported”).

## OTHER REFERENCE LINKS

1 Recent References on Quercetin: from PubMed.gov (https://www.ncbi.nlm.nih.gov/sites/entrez?cmd=search&db=pubmed&pubmedfilters=true&term=Quercetin+AND+Human%5BMH%5D+AND+(drug+induced+liver+injury+OR+jaundice/CI+OR+bile+duct+diseases/CI+OR+liver/DE+OR+liver+diseases/CI)+AND+(%221900/1/1%22%5BEDat%5D:%222999/12/31%22%5BEDat%5D))
2 Trials on Quercetin: from ClinicalTrials.gov (https://clinicaltrials.gov/ct2/results?term=Quercetin)